# Sacubitril-Valsartan

## OVERVIEW

### Introduction

Sacubitril is an orally available neprilysin inhibitor used to treat hypertension and chronic heart failure usually in combination with valsartan. Sacubitril combined with valsartan has been linked to transient and mild-to-moderate serum aminotransferase elevations during therapy and possibly to rare instances of acute liver injury with jaundice.

### Background

Sacubitril (sak ue’ bi tril) is a small molecule inhibitor of neprilysin which is used in a fixed combination with valsartan to treat heart failure. Neprilysin is a naturally occurring neutral endopeptidase that breaks down vasoactive peptides such as natriuretic peptides. By inhibiting neprilysin, sacubitril raises levels of these peptides that cause vascular dilation and increased sodium excretion. By itself, however, sacubitril has little antihypertensive or diuretic effect, probably because neprilysin also increases angiotensin levels. For this reason, sacubitril is combined with valsartan, an angiotensin II receptor blocker. The fixed combination of sacubitril and valsartan was shown to have a greater antihypertensive effect than valsartan alone and to a decrease in hospitalizations for heart failure and death from cardiovascular disease. This combination under the brand name of Entresto was approved for use as therapy in adults with chronic heart failure in the United States in 2015. Indications were later extended to children 1 year of age or older and to patients with acute decompensated heart failure. Sacubitril-valsartan is available as a single tablet in 3 fixed concentrations: 24/26 mg, 49/51 mg, and 97/103 mg. The recommended dose is one tablet twice daily starting with 49/51 and titrating up based upon tolerance to 97/103 mg in adults. The dose in children is based upon age and body weight. The most common side effects include hyperkalemia, hypotension, dry cough, headache, nausea and vomiting, and reduced renal function. Uncommon but potentially severe adverse reactions include angioedema and hypersensitivity reactions. Most of the side effects including angioedema occur at a similar rate in patients treated with valsartan or other angiotensin blocking agents alone. Sacubitril-valsartan has a boxed warning on use in pregnancy because valsartan can cause injury and death to the developing fetus.

### Hepatotoxicity

The large prospective, placebo-controlled trials of sacubitril-valsartan in patients with heart failure usually did not mention or list ALT elevations or severe hepatic adverse events or deaths. In the FDA clinical review of data from these trials, elevations in ALT or AST were said to arise in 1.3% of patients on sacubitril-valsartan but a similar portion of those on enalapril [1.0%], and all elevations were judged to be unrelated to therapy and likely due to congestive liver disease due to heart failure. A single case of jaundice with aminotransferase elevations occurred, but in a patient who had stopped combination therapy because of worsening renal dysfunction and who was experiencing acute decompensated heart failure. Since approval and more widespread use of sacubitril-valsartan there have been at least two reports of acute liver injury attributed to its use. Both cases were relatively mild and resolved rapidly once the drug was stopped. Whether the injury was due to sacubitril or valsartan (or an interaction of both) was not clear. Valsartan, like other commonly used angiotensin receptor blockers, is known to be a rare cause of acute liver injury. The contribution of the underlying heart failure and possible congestive hepatopathy is also an issue. The reported cases did not have a liver biopsy and were not rechallenged with the drug which might have clarified the causality.

Likelihood score: D (possible rare cause of clinically apparent liver injury, which may be due to valsartan rather than sacubitril).

### Mechanism of Injury

The acute hepatotoxicity caused by the combination of sacubitril and valsartan appears to be idiosyncratic and is usually mild and self-limited in course if the drug is withdrawn promptly. Sacubitril-valsartan as well as other angiotensin receptor blockers can cause acute hypersensitivity reactions including angioedema suggesting that liver injury also may be immune mediated.

### Outcome and Management

Most cases of acute hepatic injury from the combination of sacubitril and valsartan resolve within 1 to 3 months of stopping the medication and without corticosteroid therapy. It is not clear whether valsartan alone might be tolerated after recovery from liver injury attributed to its combination with sacubitril, but it is probably prudent to use a different angiotensin receptor blocking agent in this situation.

Drug Class: Cardiovascular Agents; Antihypertensive Agents [Sacubitril-Valsartan, Heart Failure Agent]

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sacubitril-Valsartan – Entresto®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sacubitril)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sacubitril | 149709-62-6 | C24-H29-NO5
Valsartan | 137862-53-4 | C24-H29-N5-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 09 July 2024

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of cardiovascular agents published in 1999 before the availability of sacubitril and valsartan).
Halegoua-DeMarzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 522-6. (Review of hepatotoxicity of cardiovascular agents published before the availability of sacubitril, but mentions that cases of hepatotoxicity of candesartan, irbesartan, losartan, and valsartan, none of which were fatal and having in both latency to onset [1 week to 6 months] and clinical presentation [cholestatic and hepatocellular]).
Hilal-Dandan R. Renin and angiotensin. In, Brunton LL, Halal R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 471-488. (Textbook of pharmacology and therapeutics).
FDA. Integrated Review. Entresto. 2015. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2015/207620Orig1s000MedR.pdf (FDA review of the data submitted in support of the approval of sacubitril-valsartan for prevention of cardiovascular death and hospitalization in patients with heart failure mentions that ALT or AST elevations above 3 times ULN arose in 1.3% of those on sacubitril-valsartan vs 1.0% on enalapril which were above 5 times ULN in 0.5% vs 0.3%, and that one patient developed marked enzyme elevations with jaundice [ALT 730 U/L], but this occurred after the combination was stopped and during acute decompensation of heart failure).
Reñé JM, Buenestado J, Sesé E, Miñana JM. Acute hepatitis induced by valsartan. Med Clin (Barc) 2001; 117: 637-8. (54 year old woman developed jaundice 18 weeks after starting valsartan for hypertension [bilirubin 23.6 mg/dL, ALT 1664 U/L, Alk P 385 U/L], resolving within 2 months of stopping). 11714476
Kiykim A, Altintas E, Sezgin O, Sezer K, Tiftik N, Akbay E, Seyrek E, et al. Valsartan-induced hepatotoxicity in a HBsAg-positive patient. Am J Gastroenterol 2003; 98: 507. (52 year old woman with hypertension and HBsAg without chronic ALT elevations developed jaundice 4 weeks after starting valsartan [peak bilirubin 7.8 mg/dL, ALT 780 U/L, Alk P 1840 U/L], resolving within 3 months of stopping). 12591083
McMurray JJ, Packer M, Desai AS, Gong J, Lefkowitz MP, Rizkala AR, Rouleau JL, et al.; PARADIGM-HF Investigators and Committees. Angiotensin-neprilysin inhibition versus enalapril in heart failure. N Engl J Med. 2014;371:993-1004. (Among 8442 patients with chronic heart failure and ejection fraction of 40% or less who were started on sacubitril-valsartan or enalapril twice daily and continued for a median of 27 months, cardiovascular deaths and hospitalizations for heart failure were less in those on the combination [21.8% vs 26.5%], and while symptomatic hypotension was more frequent with sacubitril-valsartan, cough and elevations in serum creatinine and potassium were more frequent with enalapril; no mention of ALT elevations, but no hepatic severe adverse events). 25176015
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US multicenter prospective study between 2004 and 2013, none were attributed to sacubitril, but one case was attributed to valsartan). 25754159
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, Chirino AR, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to sacubitril or valsartan). 24552865
Havakuk O, Elkayam U. Angiotensin receptor-neprilysin inhibition. J Cardiovasc Pharmacol Ther. 2017;22:356-364. (Review of the mechanism of action and history of development of neprilysin inhibitors and the importance of angiotensin II receptor blockage during their use with an in-depth review of the PARADIGM trial [McMurray 2014] of sacubitril-valsartan for heart failure with reduced cardiac ejection fraction; no mention of ALT elevations or hepatotoxicity). 28587583
Velazquez EJ, Morrow DA, DeVore AD, Duffy CI, Ambrosy AP, McCague K, Rocha R, Braunwald E; PIONEER-HF Investigators. Angiotensin-neprilysin inhibition in acute decompensated heart failure. N Engl J Med. 2019;380:539-548. (Among 881 patients hospitalized for acute heart failure started on sacubitril-valsartan or enalapril twice daily for 8 weeks, serum levels of NT-proBNP decreased by 47% with the combination vs only 25% with enalapril, while the frequency and types of treatment emergent adverse events were similar in both groups; no mention of ALT levels or hepatotoxicity). 30415601
Drugs for chronic heart failure. Med Lett Drugs Ther. 2019;61(1569):49-54. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of medications approved for use in the US for treatment of heart failure, mentions that the combination of a neprilysin inhibitor and angiotensin receptor inhibitor is the preferred first line therapy for chronic heart failure and includes discussion of sacubitril-valsartan adverse events, but does not mention hepatotoxicity or ALT elevations). 31169796
Solomon SD, McMurray JJV, Anand IS, Ge J, Lam CSP, Maggioni AP, Martinez F, et al.; PARAGON-HF Investigators and Committees. Angiotensin-neprilysin inhibition in heart failure with preserved ejection fraction. N Engl J Med. 2019;381:1609-1620. (Among 4822 patients with heart failure and preserved cardiac ejection fraction [45% or greater] but elevations in natriuretic peptide levels who were treated with sacubitril-valsartan or valsartan with a median follow up of 35 months, the primary outcome of cardiovascular death or hospitalizations for heart failure occurred less often with combination therapy but the differences were not statistically significant; combination therapy was associated with higher rates of hypotension and angioedema but lower rates of serum creatinine and potassium elevations; hepatic adverse events arose in similar proportions of both groups [6.3% vs 7.5%], but there were no severe hepatic adverse events). 31475794
Achuthanandan S, Dhaliwal A, Patti R. Drug-induced liver injury from sacubitril-valsartan versus a single dose of acarbose. Cureus. 2022;14:e27005. (76 year old woman with heart failure developed fatigue and liver test abnormalities one month after starting sacubitril-valsartan and one day after taking a single dose of acarbose for diabetes [bilirubin 1.2 mg/dL, ALT 1652 U/L, Alk P 55 U/L, INR 2.8], with rapid improvement on stopping both drugs and normal liver tests 3 weeks later). 35989811
Zhang T, Cai JL, Yu J. Sacubitril/valsartan-induced liver injury: A case report and literature review. Medicine (Baltimore). 2023;102:e34732. (90 year old Chinese woman with heart failure and HBsAg without HBV DNA developed mild elevations in ALT within a week of starting sacubitril-valsartan, which worsened on continuation to a peak one month later [bilirubin 1.4 mg/dL, ALT 640 U/L, Alk P not provided], falling once sacubitril-valsartan was stopped and with normal values 6 weeks later). 37565914
Lerman TT, Greenberg N, Fishman B, Goldman A, Talmor-Barkan Y, Bauer M, Goldberg I, et al. The real-world safety of sacubitril/valsartan among older adults (≥75): A pharmacovigilance study from the FDA data. Int J Cardiol. 2024;397:131613. (Review of the FDA’s Adverse Event Reporting System [FAERS] for sacubitril-valsartan and angiotensin II receptor blockers [ARBs] from 2004 to 2022 identified 18,435 reports, 5802 in elderly subjects [75 years or above] and, compared to ARBs, sacubitril-valsartan had higher rates of hypotension and hyperkalemia but similar rates of angioedema; no mention of ALT elevations or hepatotoxicity). 38030039
Morrow DA, Velazquez EJ, Desai AS, DeVore AD, Lepage S, Park JG, Sharma K, et al. Sacubitril/valsartan in patients hospitalized with decompensated heart failure. J Am Coll Cardiol. 2024;83:1123-1132. (Pooled analysis of controlled trials of sacubitril-valsartan versus an angiotensin receptor blocker [ARB] alone in 1347 patients with heart failure and the full spectrum of left ventricular ejection fraction [both ≤ 40% and >40%], found that cardiovascular deaths and hospitalizations were reduced by 30% regardless of ejection fraction and the combination had higher rates of hypotension and hyperkalemia but numerically lower rates to death, angioedema, and worsening of renal function; no mention of ALT elevations or hepatotoxicity). 38508844

## OTHER REFERENCE LINKS

Recent References on Sacubitril: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sacubitril+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Sacubitril: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sacubitril)